# Candesartan

## OVERVIEW

### Introduction

Candesartan is an angiotensin II receptor blocker used widely in the therapy of hypertension and heart failure. Candesartan is associated with a low rate of transient serum aminotransferase elevations and has been linked to rare instances of acute liver injury.

### Background

Candesartan (kan" de sar' tan) is an angiotensin II receptor blocker (ARB) that is widely used alone or in combination with other agents as therapy of hypertension and heart failure. Candesartan inhibits the renin-angiotensin system by blocking the angiotensin II type 1 receptor (AT1), which prevents the vasoconstriction and volume expansion induced by circulating angiotensin II, accounting for its antihypertensive activity. Candesartan was approved for use in the United States in 1998 and is available in 4, 8, 16 and 32 mg tablets generically and under the trade name Atacand. Current indications include treatment of hypertension (usually in combination with other agents) and to prevent cardiovascular events and death in patients with chronic heart failure. The typical dose of candesartan in adults is 16 to 32 mg once daily, and it is used long term. Candesartan is also available in fixed combinations with hydrochlorothiazide (Atacand HCT and others). Side effects of candesartan are uncommon, but may include headache, dizziness, fatigue, cough, gastrointestinal upset and fetal toxicity. Many ARBs, but not specifically candesartan, have been linked to cases of a severe sprue-like enteropathy that presents with severe diarrhea and weight loss and villous flattening and atrophy on intestinal biopsy arising after months or years of ARB use. The enteropathy resembles celiac disease but does not repond to a gluten-free diet, but resolves promptly with stopping the angiotensin receptor blocker.

### Hepatotoxicity

Candesartan has been associated with a low rate of serum aminotransferase elevations (<1%) that in controlled trials was no higher than with placebo therapy. These elevations were transient and rarely required dose modification. Rare instances of clinically apparent acute liver injury have been reported in association with candesartan therapy. The onset is usually within 1 to 8 weeks of starting therapy and the serum enzyme pattern can be either hepatocellular or cholestatic with an acute hepatitis- or cholestatic hepatitis-like clinical syndrome. In some instances, cholestasis can be prolonged and relapsing, but candesartan therapy has not been associated with vanishing bile duct syndrome or chronic liver injury. Immunoallergic manifestations (rash, fever, eosinophilia) are not common, nor is autoantibody formation.

Likelihood score: C (Probable cause of rare instances of clinically apparent liver injury).

### Mechanism of Injury

The cause of the minor serum aminotransferase elevations and the acute liver injury associated with candesartan is not known, but resembles idiosyncratic liver injury due to a hypersensitivity reaction. Candesartan has minor liver metabolism through the cytochrome P450 system (CYP 2C9) and has minimal drug-drug interactions.

### Outcome and Management

The instances of acute liver injury reported with candesartan use have been self limited and have not resulted in acute liver failure or chronic liver injury. While corticosteroids have been used in cases of severe cholestasis due to ARBs, their efficacy has not been shown and their use is best avoided. Patients with candesartan induced acute liver injury should probably avoid use of other ARBs, although cross sensitivity to liver injury among the members of this class of agents has not been shown.

References on the safety and potential hepatotoxicity of candesartan are given in the Overview section on the angiotensin II receptor antagonists.

Drug Class: Antihypertensive Agents, Angiotensin II Receptor Antagonists

Other Drugs in the Subclass, Angiotensin II Receptor Antagonists: Azilsartan, Eprosartan, Irbesartan, Losartan, Olmesartan, Telmisartan, Valsartan

## CASE REPORT

### Case 1. Severe hepatitis attributed to candesartan.

[Modified from: Basile G, Villari D, Gangemi S, Ferrara T, Accetta MG, Nicita-Mauro V. Candesartan cilexetil-induced severe hepatotoxicity. J Clin Gastroenterol 2003; 36: 273-5. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/12590242)]

A 61 year old woman with hypertension started therapy with candesartan cilexetil (16 mg daily) and developed fever, anorexia, nausea, abdominal pain and jaundice approximately 4 weeks later. She had no history of liver disease, alcohol abuse, risk factors for viral hepatitis or previous serious drug reactions. On examination, she had jaundice and low grade fever (37.8 oC). Laboratory tests showed marked elevations in serum bilirubin (27.2 mg/dL) and serum aminotransferase levels (ALT 918 U/L, AST 1367 U/L) with minimal increase in alkaline phosphatase (142 U/L), LDH (700 U/L: normal <460 U/L) and GGT (49 U/L) (Table). The prothrombin index was reduced at 52% (normal 70% to 120%). Tests for hepatitis A, B and C were negative and antinuclear antibody titers were minimally increased (1:40). Ultrasound and CT of the abdomen showed mild hepatomegaly and minimal ascites without evidence of biliary obstruction. A liver biopsy showed acute hepatocellular necrosis and inflammation but also cholestasis, ductopenia and biliary epithelial injury. There was mild fibrosis. Because of rising levels of serum bilirubin (peak 46.8 mg/dL), she was treated with a seven week course of methylprednisolone (40 mg/day for 3 weeks, 20 mg/day for 2 weeks, and 8 mg/day for two weeks). There was a gradual improvement in the patient’s condition and she was discharged after 8 weeks in the hospital. One month later, all liver tests were repeated and were normal.

#### Key Points

Medication: | Candesartan (16 mg daily)
Pattern: | Hepatocellular (R=13)
Severity: | 4+ (jaundice, prothrombin time prolongation and ascites)
Latency: | 4 weeks
Recovery: | 8-12 weeks
Other medications: | None mentioned

#### Laboratory Values

Weeks After Starting | Weeks After Stopping | ALT (U/L) | Alk P (U/L) | Bilirubin (mg/dL) | Other
4 | 0 | 918 | 142 | 27.2 | Admission
5 | 1 | 386 | | 39.1 | Corticosteroids started
6 | 2 | 260 | 405 | 46.8
7 | 3 | 144 | 97 | 26.2
10 | 5 | 47 | 176 | 3.8
13 | 8 | 20 | 93 | 1.2 | Corticosteroids stopped
Normal Values | | <58 | <117 | <1.2

#### Comment

The patient developed an acute hepatitis-like clinical syndrome one month after starting candesartan for hypertension. No other cause of acute liver injury was identified, and a liver biopsy showed changes that were compatible with drug induced liver disease (mixed hepatocellular and biliary injury). Corticosteroids were given because of the severity of the injury and recovery, while delayed, was ultimately complete within 8 to 12 weeks of onset. Whether the corticosteroids prompted or sped recovery is uncertain, but importantly, the methylprednisone dose was quickly lowered and stopped. Clinically apparent acute liver injury from angiotensin receptor antagonists is exceedingly rare, but the timing of onset and recovery and liver biopsy findings in this case were convincing. In view of the severity of the injury and the availability of other medications to treat hypertension, rechallenge with candesartan is not warranted.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Candesartan – Atacand®

DRUG CLASS

Angiotensin II Receptor Antagonists

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Candesartan)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Candesartan | 139481-59-7 | C24-H20-N6-O3 | Chemical Structure for Candesartan

## OTHER REFERENCE LINKS

1. Recent References on Candesartan: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Candesartan+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Candesartan: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Candesartan)